# Rifamycin

## OVERVIEW

### Introduction

Rifamycin is a nonabsorbable rifampin-like antibacterial agent that is used as treatment of travelers’ diarrhea. Rifamycin has minimal oral absorption and has not been implicated in causing liver test abnormalities or clinically apparent liver injury.

### Background

Rifamycin (rif" a mye' sin) is a semisynthetic derivative of rifampin specifically designed to have minimal gastrointestinal absorption (<0.1%). It is a broad spectrum antibiotic with activity against both aerobic and anaerobic organisms, both gram negative and gram positive. The antibiotic activity is attributed to rifamycin’s binding to bacterial RNA polymerases, preventing RNA and subsequent protein synthesis. Rifamycin is formulated with enteric coating and a multi-matrix technology that prevents the dissolving until it reaches the cecum where the higher pH (above 7) allows for the delivery of the drug throughout the colon. The delayed dissolution of the tablet prevents the antibacterial activity from acting on small bowel flora and targets it largely at the colon. This delayed release formulation of rifamycin was approved for use as treatment of travelers’ diarrhea in 2018. Rifamycin is available in tablets of 200 mg under the brand name Aemcolo. The recommended dose is 400 mg (2 tablets) twice daily for 3 days. Side effects are uncommon but can include headache and constipation. Rare instances of hypersensitivity and Clostridium difficile-associated diarrhea have been described.

### Hepatotoxicity

In prelicensure controlled trials in patients with traveler’s diarrhea, rates of serum ALT elevations were similar in subjects treated with rifamycin compared to placebo or comparator agent (ciprofloxacin) and no participants developed clinically apparent liver injury. Since its approval, there have been no published reports of hepatotoxicity attributed to rifamycin. Because of its minimal absorption rifamycin is considered unlikely to cause liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Rifamycin has minimal systemic absorption and is unlikely to reach serum concentrations that might be hepatotoxic or induce CYP 3A4 enzyme activity or inhibit hepatic organic anion transport proteins, which the native compound has been shown to affect.

Other agents used for travelers’ diarrhea include rifaximin, azithromycin and ciprofloxacin.

Drug Class: Antiinfective Agents; Gastrointestinal Agents, Antidiarrheals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rifamycin – Aemcolo®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Rifamycin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Rifamycin | 6998-60-3 | C37-H47-N-O12 | Rifamycin Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 11 April 2019

Zimmerman HJ. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 598. (Expert review of hepatotoxicity published in 1999; rifampin is discussed but not rifamycin or rifaximin).
Verma S, Kaplowitz N. Hepatotoxicity of antituberculosis drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 483-504. (Review of hepatotoxicity of antituberculosis drugs; rifampin can induce microsomal CYP enzymes as well as inhibit bilirubin update or excretion; rifamycin is not discussed).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that serum enzyme elevations were uncommon during rifamycin therapy and no more frequent that with placebo or a comparator therapy [ciprofloxacin]; two subjects developed elevations in serum bilirubin with concurrent increases in ALT and AST, but in both instances the abnormalities were not thought to be due to rifamycin).
DuPont HL, Jiang ZD, Okhuysen PC, Ericsson CD, de la Cabada FJ, Ke S, DuPont MW, et al. A randomized, double-blind, placebo-controlled trial of rifaximin to prevent travelers' diarrhea. Ann Intern Med 2005; 142: 805-12. (In a trial in 210 adult US student-travelers to Mexico randomized to take rifaximin or placebo for 2 weeks, there was a decrease in diarrheal illness with rifaximin [15% vs 54%]; there were no "clinically significant" patterns of laboratory abnormalities found). 15897530
Steffen R, Hill DR, DuPont HL. Traveler's diarrhea: a clinical review. JAMA 2015; 313 (1): 71-80. (Review of the incidence, etiology and management of travelers’ diarrhea; rates vary from 10-40% largely dependent upon the destination and duration of exposure, as well as where meals are purchased; causes include enterotoxigenic E. coli, noroviruses, Salmonella, Shigella and Campylobacter species; prevention depends on dietary precautions; prophylaxis and treatments include bismuth subsalicylate, ciprofloxacin and rifaximin; complications may include bloody diarrhea, post-infectious irritable bowel syndrome, reactive arthritis, and Guillain-Barre syndrome). 25562268
DuPont HL, Petersen A, Zhao J, Mundt A, Jiang ZD, Miller S, Flores J, et al. Targeting of rifamycin SV to the colon for treatment of travelers' diarrhea: a randomized, double-blind, placebo-controlled phase 3 study. J Travel Med 2014; 21: 369-76. (Among 264 patients with travelers’ diarrhea treated with a 3-day course of rifamycin or placebo, the duration of diarrhea was shorter [46 vs 68 hours] and clinical cure rate higher [81% vs 57%] with rifamycin, while advance event rates were lower [30% vs 38.5%] and “no drug effects on renal or liver function test results were identified”). 25345982
Jiang ZD, DuPont HL. Etiology of travellers' diarrhea. J Travel Med 2017; 24 (suppl_1): S13-S16. (Review of 11 studies on the etiology of travelers’ diarrhea; overall bacterial pathogens were identified in 72-80% of cases, most commonly E. coli and for non-bacterial cases, norovirus in 3-10%). 28521001
Steffen R, Jiang ZD, Gracias Garcia ML, Araujo P, Stiess M, Nacak T, GreinwaldR, DuPont HL. Rifamycin SV-MMX® for treatment of travelers' diarrhea: equally effective as ciprofloxacin and not associated with the acquisition of multi-drug resistant bacteria. J Travel Med 2018; 25 (1). (Among 835 travelers with diarrhea treated with rifamycin [400 mg twice daily] or ciprofloxacin [500 mg twice daily] for 3 days, time to cure was similar [43 vs 37 hours] as were adverse event rates [8.1% vs 7.5%] and no serious adverse events occurred). 30462260
Rifamycin (Aemcolo) for treatment of travelers' diarrhea. Med Lett Drugs Ther 2019; 61 (1567): 39-40. (Concise review of the mechanism of action, clinical efficacy, safety and costs of rifamycin shortly after its approval as therapy of travelers' diarrhea in the US, does not mention ALT elevations or hepatotoxicity). 30845098

## OTHER REFERENCE LINKS

1. Recent References on Rifamycin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Rifamycin/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Rifamycin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Rifamycin)